# Mitoxantrone

## OVERVIEW

### Introduction

Mitoxantrone is an antineoplastic antibiotic that is used in the treatment of acute leukemia, lymphoma, and prostate and breast cancer, but also for late stage, severe multiple sclerosis. Mitoxantrone therapy is often accompanied by mild to moderate elevations in serum aminotransferase levels, but in typical doses it rarely causes clinically apparent, acute liver injury.

### Background

Mitoxantrone (mye tox’ an trone) is an antineoplastic antibiotic that is a synthetic derivative of doxorubicin and is considered an anthracenedione. It is believed to act by intercalating into helical double-stranded DNA causing cross links and strand breaks, thus blocking both DNA and RNA synthesis. Mitoxantrone has potent antitumor effects in vitro and has been evaluated in leukemia, lymphoma and several solid tumors in humans. Mitoxantrone also has immunosuppressive activity, inhibiting B cell, T cell and macrophage proliferation and decreasing tumor necrosis factor alpha and interleukin-2 secretion. These actions led to its evaluation in patients with progressive forms of multiple sclerosis where it was shown to have activity in decreasing the rates of relapse and development of new lesions. Mitoxantrone was approved for use in the United States in 1987 and current indications include acute non-lymphocytic leukemia and advanced prostate cancer. Mitoxantrone was subsequently approved for use in secondary progressive forms, progressive-relapsing forms and worsening relapsing-remitting forms of multiple sclerosis. Because of its potential long term toxicities (heart failure and cancer), mitoxantrone has been largely replaced by safer and perhaps more effective agents such as natalizumab. Mitoxantrone is available in several generic formulations as a solution for intravenous injection (usually 2 mg/mL). Mitoxantrone is administered intravenously in doses typically ranging from 12 to 14 mg/m^2^ at intervals of every 3 months (multiple sclerosis) or in monthly cycles (prostate cancer and leukemia). Side effects of mitoxantrone include bone marrow suppression, nausea, vomiting, abdominal discomfort, diarrhea, alopecia, headache, dizziness and rash. Serious side effects include febrile neutropenia, cardiac toxicity [similar to that caused by doxorubicin] and secondary leukemia [in patients with multiple sclerosis]. Mitoxantrone should be administered by a physician experienced in the use of cytotoxic chemotherapy and must be given intravenously slowly and carefully, as it can cause severe local tissue damage and should not be given subcutaneously, intramuscularly or intrathecally.

### Hepatotoxicity

Chemotherapy with mitoxantrone alone is associated with serum enzyme elevations in up to 40% of patients, but these elevations are generally mild-to-moderate in severity, transient and not accompanied by symptoms or jaundice. Higher rates of liver enzyme elevations have been reported with combination chemotherapeutic regimens that include mitoxantrone. In high doses, mitoxantrone has been associated with a high rate of jaundice, but the degree of hyperbilirubinemia has been mild, transient and not associated with significant serum enzyme elevations or evidence of hepatitis. Rare instances of acute liver injury have been reported in patients taking mitoxantrone, including a single case of drug-rash with eosinophilia and systemic symptoms (DRESS). The latency to onset was 8 weeks and the pattern of serum enzyme elevations was cholestatic and later mixed. Immunoallergic features were prominent and appeared to respond to corticosteroid therapy. Other drugs were being taken and the association with mitoxantrone was not definite (Case 1). Thus, idiosyncratic and clinically apparent liver injury from mitoxantrone may occur but is quite rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The transient ALT elevations that can occur during mitoxantrone therapy are likely due to direct toxicity of the drug or its metabolites. Idiosyncratic acute liver injury attributed to mitoxantrone is likely due to a hypersensitivity reaction. Mitoxantrone is at least partially metabolized by the liver, but the specific pathways have not been well defined.

### Outcome and Management

The serum aminotransferase and mild serum bilirubin elevations that frequently accompany mitoxantrone therapy are generally self-limited, transient and unaccompanied by symptoms. The product label recommends regular monitoring of serum aminotransferase levels before each monthly or every-three-month infusion of mitoxantrone therapy, but dose modifications or discontinuation are rarely necessary. Patients who develop immunoallergic reactions to mitoxantrone should not be rechallenged with the medication. The possibility of cross reactivity with doxorubicin or other cytotoxic anthracycline antibiotics has not been evaluated, but should be done with caution.

Drug Class: Antineoplastic Agents (https://www.ncbi.nlm.nih.gov/books/n/livertox/AntineoplasticAgents/); Multiple Sclerosis Agents (https://www.ncbi.nlm.nih.gov/books/n/livertox/MultipleSclerosisAge/)

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Bleomycin, Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Plicamycin

## CASE REPORT

### Case 1. Drug reaction with eosinophilia and systemic signs (DRESS) attributed to mitoxantrone therapy.(1)

A 44 year old woman with primary, progressive multiple sclerosis developed jaundice 8 weeks after starting mitoxantrone (10 mg every 4 weeks) and piracetam (3 gm daily). She was known to have multiple sclerosis for 3 years and had been treated previously with interferon beta with little clinical improvement. At the time of her third scheduled dose of mitoxantrone, she was found to be jaundiced and had mild fever and facial edema. Laboratory testing showed a total serum bilirubin of 19.3 mg/dL which was primarily direct. Serum ALT was 561 U/L, AST 337 U/L, alkaline phosphatase 705 U/L, GGT 447 U/L. These values had been normal in the past (Table). She took no other medications except for baclofen (75 mg daily), which she had been taking for almost two years. Her medications were stopped and she was admitted for evaluation. Tests for hepatitis A, B and C were negative as were routine autoantibodies. Abdominal ultrasound and magnetic resonance imaging were normal, without evidence of biliary obstruction. However, she failed to improve and after two weeks, her serum bilirubin remained high. A liver biopsy showed canalicular cholestasis with mild portal inflammation suggestive of drug induced liver injury. One week later, she developed a generalized, erythematous, macular rash and laboratory testing demonstrated leukocytosis (15,300/μL) and eosinophilia (>4000/μL). Methylprednisone was stated (20 mg daily) and she improved rapidly. Six months after initial presentation, all liver tests were normal and she underwent drug sensitivity skin testing which showed marked reactions to mitoxantrone, but none to piracetam.

#### Key Points

Medication: | Mitoxantrone (10 mg intravenously, 2 doses)
Pattern: | Cholestatic (R=1.9)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 months
Recovery: | 6 months
Other medications: | Piracetam, baclofen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal
8 weeks | 0 | 561 | 705 | 19.3 | Fever, facial edema
10 weeks | 2 weeks | | | 19.9 | Liver biopsy
11 weeks | 3 weeks | 647 | 693 | 18.1 | Rash, corticosteroids started
13 weeks | 5 weeks | | | 8.5 | Discharged
8 months | 6 months | Normal | Normal | Normal | Skin testing
Normal Values | | <45 | <115 | <1.2

#### Comment

A woman with multiple sclerosis developed jaundice and fever 8 weeks after starting the combination of mitoxantrone and piracetam. She did not improve immediately after stopping the medications and 3 weeks later developed skin rash and eosinophilia, fully warranting a diagnosis of DRESS syndrome. A liver biopsy demonstrated canalicular cholestasis, which is typical of the intrahepatic cholestasis that is caused by medications. The immunoallergic features of DRESS syndrome improved rapidly with methylprednisolone therapy (the duration of which was unclear), and serum bilirubin began to fall. In follow up 6 months later, she had recovered completely. Skin testing suggested that mitoxantrone rather than piracetam was the cause of the hypersensitivity reaction. Piracetam is a synthetic derivative of GABA, similar in structure to levetiracetam and used as treatment of myoclonus and for cognitive impairment. It is commercially available in Europe and elsewhere, but is not approved for use in the United States. While piracetam has not been specifically linked to hypersensitivity reactions, levetiracetam has been linked to cases of DRESS and Stevens Johnson syndrome. Thus, piracetam may have been the cause of the DRESS syndrome but, without rechallenge (negative or positive), it is impossible to definitively link this outcome to either agent. Certainly, the skin test reactions favor but do not prove the contribution of mitoxantrone.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mitoxantrone – Generic, Novantrone®

DRUG CLASS

Antineoplastic Agents; Multiple Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mitoxantrone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mitoxantrone | 70476-82-3 | C22-H28-N4-O6.2Cl-H

## CITED REFERENCE

1 Caruso A, Vecchio R, Patti F, Neri S. Drug rash with eosinophilia and systemic signs syndrome in a patient with multiple sclerosis. Clin Ther 2009; 31: 580-4.19393848

## ANNOTATED BIBLIOGRAPHY

References updated: 04 December 2025

Zimmerman HJ. Anthracycline antibiotics. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 696-7. (Expert review of hepatotoxicity published in 1999 mentions that mitoxantrone is associated with ALT elevations in 40% of patients when used alone and in 80% when used in combination chemotherapy, but the abnormalities are usually minor and "pose no important threat").
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 553. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that mitoxantrone causes transient abnormalities in bilirubin and aminotransferase levels).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-203. (Textbook of pharmacology and therapeutics mentions that mitoxantrone is approved for use in acute non-lymphocytic leukemia, prostate cancer and late stage, progressive multiple sclerosis).
Paciucci PA, Sklarin NT. Mitoxantrone and hepatic toxicity. Ann Intern Med 1986; 105: 805-6. (Among 26 patients with leukemia treated with mitoxantrone, transient ALT and AST elevations occurred in 42% and bilirubin in 4%, 4-24 days after 5 day courses of the antineoplastic agent, resolving rapidly thereafter; among 19 patients treated with mitoxantrone, vincristine and prednisone, ALT elevations occurred after 80% of courses). 3767174
Shenkenberg TD, Von Hoff DD. Mitoxantrone: a new anticancer drug with significant clinical activity. Ann Intern Med 1986; 105: 67-81. (Review of the biochemistry, mechanism of action, pharmacokinetics, clinical efficacy and safety of mitoxantrone in cancer chemotherapy; common side effects are mucositis, bone marrow suppression, and gastrointestinal intolerance; hepatotoxicity and ALT elevations were not mentioned). 3521429
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987; 7: 237-56. (Overview of hepatotoxicity of antineoplastic agents, mentions that hepatotoxicity is not invariably described as a toxicity of mitoxantrone, suggesting that it is rare). 3317861
Vredenburgh JJ, McIntyre OR, Cornwell GG 3rd, Ball ED, Cornell CJ, Mills LE, O'Donnell JF. Mitoxantrone in relapsed or refractory acute nonlymphocytic leukemia. Med Pediatr Oncol 1988; 16: 187-9. (Among 17 patients with relapsed or refractory acute non-lymphocytic leukemia [ANLL] treated with 3 day courses of mitoxantrone, 9 [53%] developed elevated liver tests [>1.5 times ULN], but authors do not mention jaundice or clinically apparent liver injury). 3380061
Motawy MS, Khalifa F, Salfiti R, Patel JP. Mitoxantrone, cytosine-arabinoside and 6-thioguanine (MAT) in the treatment of newly diagnosed acute non-lymphoblastic leukemia in adults. Anticancer Drugs 1992; 3: 475-9. (Among 28 patients with newly diagnosed ANLL treated with 58 courses of mitoxantrone, cytarabine and thioguanine, major toxicities were bone marrow suppression, nausea, vomiting and stomatitis; hepatotoxicity occurred during 14 [24%] courses with Alk P elevation in all, ALT in 8 and bilirubin in 1, which resolved within an average of 12 days and did not recur upon reexposure). 1450441
Feldman EJ, Alberts DS, Arlin Z, Ahmed T, Mittelman A, Baskind P, Peng YM, et al. Phase I clinical and pharmacokinetic evaluation of high-dose mitoxantrone in combination with cytarabine in patients with acute leukemia. J Clin Oncol 1993; 11: 2002-9. (Study of increasing doses of mitoxantrone [40 to 80 mg/m2/day for 2 days] in combination with cytarabine in 68 patients with leukemia found severe [>3 times ULN], but reversible hyperbilirubinemia in 32% of patients, with no mention of ALT elevations or symptomatic liver injury). 8410125
Avilés A, Guzmán R, Talavera A, García EL, Díaz-Maqueo JC. Randomized study for the treatment of adult advanced Hodgkin's disease: epirubicin, vinblastine, bleomycin, and dacarbazine (EVBD) versus mitoxantrone, vinblastine, bleomycin, and dacarbazine (MVBD). Med Pediatr Oncol 1994; 22: 168-72. (Among 70 patients with Hodgkin disease treated with vinblastine, bleomycin and dacarbazine combined with either epirubicin or mitoxantrone, 6 of those receiving mitoxantrone, but none receiving epirubicin, developed liver test abnormalities [>3 times ULN], which became chronic in two). 7505877
Millefiorini E, Gasperini C, Pozzilli C, D'Andrea F, Bastianello S, Trojano M, Morino S, et al. Randomized placebo-controlled trial of mitoxantrone in relapsing-remitting multiple sclerosis: 24-month clinical and MRI outcome. J Neurol 1997; 244: 153-9. (Among 51 patients with relapsing multiple sclerosis enrolled in a 2 year controlled trial of mitoxantrone versus placebo, side effects included nausea, diarrhea, and amenorrhea; no mention of ALT elevations or hepatotoxicity). 9050955
Edan G, Miller D, Clanet M, Confavreux C, Lyon-Caen O, Lubetzki C, Brochet B, et al. Therapeutic effect of mitoxantrone combined with methylprednisolone in multiple sclerosis: a randomised multicentre study of active disease using MRI and clinical criteria. J Neurol Neurosurg Psychiatry 1997; 62: 112-8. (Among 42 patients with active multiple sclerosis treated with once monthly, intravenous methylprednisolone [MP] alone or with mitoxantrone, side effects of mitoxantrone included amenorrhea, stomatitis, nausea and vomiting; one patient on MP alone developed "hepatitis", but no details given). 9048709
Faggioli P, De Paschale M, Tocci A, Luoni M, Fava S, De Paoli A, Tosi A, Cassi E. Acute hepatic toxicity during cyclic chemotherapy in non-Hodgkin’s lymphoma. Haematologica 1997; 82: 38-42. (Among 98 patients with lymphoma treated with various combinations of chemotherapy [21 received mitoxantrone], 20 had transient ALT elevations and 12 developed acute hepatitis, 8 in HBsAg positive patients and probably due to reactivation). 9107080
Bennett JM, Young MS, Liesveld JL, Paietta E, Miller KB, Lazarus HM, Marsh RD, et al. Phase II study of combination human recombinant GM-CSF with intermediate-dose cytarabine and mitoxantrone chemotherapy in patients with high-risk myelodysplastic syndromes (RAEB, RAEBT, and CMML): an Eastern Cooperative Oncology Group Study. Am J Hematol 2001; 66: 23-7. (Among 10 elderly patients with myelodysplastic syndromes treated with cytarabine, mitoxantrone and GM-CSF, bilirubin elevations occurred in 7 [2.2-22.4 mg/dL], but AST was raised in only 1 and alkaline phosphatase in 3 patients; 7 patients died of infectious complications). 11426487
Schaich M, Illmer T, Aulitzky W, Bodenstein H, Clemens M, Neubauer A, Repp R, et al.; SHG AML96 Study Group. Intensified double induction therapy with high dose mitoxantrone, etoposide, m-amsacrine and high dose ara-C for elderly acute myeloid leukemia patients aged 61-65 years. Haematologica 2002; 87: 808-15. (Among 33 patients with acute myeloid leukemia treated with intensive chemotherapy with mitoxantrone, "grade 3 or 4 toxicity of the gastrointestinal tract and the liver" occurred in 48% of patients compared to only 21% of 39 patients given conventional chemotherapy). 12161356
Hartung HP, Gonsette R, König N, Kwiecinski H, Guseo A, Morrissey SP, Krapf H, Zwingers T; Mitoxantrone in Multiple Sclerosis Study Group (MIMS). Mitoxantrone in progressive multiple sclerosis: a placebo-controlled, double-blind, randomised, multicentre trial. Lancet 2002; 360 (9350): 2018-25. (Among 188 patients with progressive multiple sclerosis enrolled in a controlled trial of mitoxantrone vs placebo infusions every 3 months for two years, common side effects to standard doses of mitoxantrone included nausea [76%], alopecia [61%], stomatitis [19%] and diarrhea [16%]; serum ALT or AST elevations occurred in 8-9% of mitoxantrone versus 8% placebo recipients; no mention of jaundice or clinically apparent liver injury). 12504397
Chaudhuri A, Behan PO. Mitoxantrone trial in multiple sclerosis. Lancet 2003; 361 (9363): 1133-4. (Letter in response to Hartung [2002] raising issues regarding the safety and efficacy of mitoxantrone in multiple sclerosis; no mention of hepatotoxicity). 12672341
Cohen BA, Mikol DD. Mitoxantrone treatment of multiple sclerosis: safety considerations. Neurology 2004; 63 (12 Suppl 6): S28-32. (Review of safety of mitoxantrone in treatment of multiple sclerosis mentions that mild-to-moderate elevations in ALT and sometimes bilirubin can occur, and recommends monitoring of routine liver tests before each infusion and deferring therapy if there are abnormalities). 15623667
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to mitoxantrone). 18955056
Caruso A, Vecchio R, Patti F, Neri S. Drug rash with eosinophilia and systemic signs syndrome in a patient with multiple sclerosis. Clin Ther 2009; 31: 580-4. (44 year old woman with multiple sclerosis developed fever, rash and jaundice 8 weeks after starting piracetam [a neuroenhancing derivative of GABA not available in the US] and mitoxantrone [bilirubin 19.3 mg/dL, ALT 561 U/L, Alk P 705 U/L, eosinophils >4000/uL], resolving with corticosteroid therapy and later having positive skin test reactions to mitoxantrone: Case 1). 19393848
Wundes A, Kraft GH, Bowen JD, Gooley TA, Nash RA. Mitoxantrone for worsening multiple sclerosis: tolerability, toxicity, adherence and efficacy in the clinical setting. Clin Neurol Neurosurg 2010; 112: 876-82. (Retrospective analysis of 96 patients with multiple sclerosis treated with 534 infusions of mitoxantrone over a 6 year period at a single referral center; common side effects were nausea [64%], fatigue [53%], infections [33%], alopecia [33%], gastrointestinal upset [22%] and amenorrhea [18% of women]; no mention of ALT elevations or hepatotoxicity). 20727669
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents [melphalan and gemtuzumab], but none to mitoxantrone). 20949552
Kümpfel T, Gerdes LA, Flaig M, Hohlfeld R, Wollenberg A. Drug-induced Sweet's syndrome after mitoxantrone therapy in a patient with multiple sclerosis. Mult Scler 2011; 17: 495-7. (55 year old man with multiple sclerosis developed acute febrile neutropenic dermatitis [Sweet syndrome], 7 days after a 5th three-monthly infusion of mitoxantrone which responded to stopping therapy and corticosteroids, but relapsed upon tapering dose; no mention of liver test results). 21148263
Kim JW, Lee HJ, Yi HG, Kim BS, Bang SM, Kim JS, Kim I, et al. Mitoxantrone, etoposide, cytarabine, and melphalan (NEAM) followed by autologous stem cell transplantation for patients with chemosensitive aggressive non-Hodgkin lymphoma. Am J Hematol 2012; 87: 479-83. (Among 69 patients with lymphoma undergoing combination chemoablation including mitoxantrone followed by HST, adverse events included mucositis [100%], febrile neutropenia [88%] and "grade 3 or 4 hepatic toxicity" in 10%, but no details given). 22388671
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, ten cases were attributed to antineoplastic agents, but none to mitoxantrone). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to mitoxantrone).
Lasek-Bal A, Bartoszek K, Steposz A, Puz P, Bal W, Kazibutowska Z. Efficacy and safety of mitoxantrone use in primary and secondary progressive multiple sclerosis - study site experience based on the therapy of 104 patients. Int J Neurosci. 2017;127:859-863.. (Among 104 patients with progressive multiple sclerosis treated between 2006 and 2015 at a single referral center in Poland, adverse events included nausea, leukopenia, infections, and hair loss but there was no mention of ALT elevations, and among 22 patients who discontinued therapy early, none were for hepatotoxicity or enzyme elevations). 27919195
Chartier N, Epstein J, Soudant M, Dahan C, Michaud M, Pittion-Vouyovitch S, Guillemin F, et al. Clinical follow-up of 411 patients with relapsing and progressive multiple sclerosis 10 years after discontinuing mitoxantrone treatment: a real-life cohort study. Eur J Neurol. 2018;25:1439-1445.. (Among 411 French patients with multiple sclerosis treated with mitoxantrone from 1995 and 2005 who were enrolled in “an exhaustive real-life database” with 10 year follow up, therapy was claimed to have “sustained benefit” [although most patients had progressive disease] and a “good” safety profile, while specific adverse events included 4 cases of heart disease and 32 malignancies [7 leukemias]; no mention of ALT elevations or hepatotoxicity). 29996003
Buttmann M. Where mitoxantrone for multiple sclerosis is still valuable in 2018. Eur J Neurol. 2018;25:1400-1401.. (Commentary on Chartier [2018] mentions that there is a robust response after mitoxantrone therapy but long-term follow up demonstrates that the vast majority have worsening disability). 30133060
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler 2019; 25: 1633-40. (Analysis of hepatic adverse events attributed to drugs used to treat multiple sclerosis reported to the FDA between 2004 and 2016 identified 4873 cases of “severe liver injury”, most commonly due to interferon beta-1a [2343], interferon beta-1b [535], natalizumab [759], fingolimod [496], dimethyl fumarate [223], and glatiramer [212], but also mitoxantrone [131]; no specific clinical details provided). 30230957
Wawrzyniak S, Rzepiński Ł. Is there a new place for mitoxantrone in the treatment of multiple sclerosis? Neurol Neurochir Pol. 2020;54:54-61.. (Among 100 patients with various forms of multiple sclerosis treated with mitoxantrone at a single Polish neurology center between 2002 and 2014 with an average total dose of 140 mg given over 1.9 years in 6.8 cycles, response rates varied by the form of multiple sclerosis, while adverse events included decrease in left ventricular dysfunction in 7, dysmenorrhea in 9 of 64 women, but no serious infections, no leukemias, and only mild and transient nausea and alopecia during or shortly after therapy; no mention of ALT elevations or hepatoxicity ). 31922582
Foo EC, Russell M, Lily O, Ford HL. Mitoxantrone in relapsing-remitting and rapidly progressive multiple sclerosis: Ten-year clinical outcomes post-treatment with mitoxantrone. Mult Scler Relat Disord. 2020;44:102330.. (Among 70 patients with multiple sclerosis treated with mitoxantrone, adverse events arose in 60%, most frequently nausea [40%], transient alopecia [21%], urinary tract infections [9%], hot flushes [7%], and amenorrhea [3%], no mention of ALT elevations or hepatotoxicity). 32599468
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for relapsing multiple sclerosis, mentions that most such agents are associated with cases of acute liver injury that are typically rare, idiosyncratic, and unpredictable; mitoxantrone and siponimod are used largely in secondary progressive disease and are not discussed). 34319570
McGinley MP, Goldschmidt CH, Rae-Grant AD. Diagnosis and treatment of multiple sclerosis: a review. JAMA. 2021;325:765-779.. (Review of the clinical features, diagnosis, and therapy of multiple sclerosis, discusses nine classes of disease modifying therapies and states that mitoxantrone, a topoisomerase inhibitor causes a dose-dependent cardiac toxicity and has been largely replaced by other agents (such as natalizumab) for progressive or resistant forms of multiple sclerosis). 33620411
Drugs for multiple sclerosis. Med Lett Drugs Ther 2021; 63(1620): 42-8. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Zrzavy T, Daniels E, Stuka N, Weber D, Winkelmann A, Rauschka H, Hecker M, et al. Rituximab versus mitoxantrone: comparing effectiveness and safety in advanced relapsing multiple sclerosis. Ther Adv Chronic Dis. 2021;12:20406223211024366.. (Among 292 adults with relapsing multiple sclerosis treated with either mitoxantrone or rituximab between 2005 and 2018 in 3 neurology centers in Austria or Germany, clinical efficacy was similar but adverse events were more frequent with mitoxantrone [68% vs 45%] which were severe in 10% vs 5% and included cardiac events in 9% vs 5.5%; no mention of ALT elevations or hepatotoxicity ). 34377385
Lefort M, Le Corre G, Le Page E, Rizzato C, Le Port D, Michel L, Kerbrat A, et al. Ten-year follow-up after mitoxantrone induction for early highly active relapsing-remitting multiple sclerosis: An observational study of 100 consecutive patients. Rev Neurol (Paris). 2022;178:569-579.. (Among 100 patients with multiple sclerosis treated with mitoxantrone [1 g monthly for 3 or 6 months] followed by disease modifying therapies with up to 10 years of follow up, 24% remained relapse free and the annual rate of relapses remained low, while adverse events during therapy included fatigue [40%], nausea [32%], hair loss [18%], minor infectious diseases [15%], and one case of “acute hepatitis” with no specific details given). 35181157
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but none to mitoxantrone or other disease modifying agents used to treat multiple sclerosis: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Mitoxantrone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mitoxantrone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Mitoxantrone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mitoxantrone)